# Immunoallergic Hepatitis

Description. Drug induced immunoallergic hepatitis is characterized by acute liver injury accompanied by signs and symptoms of hypersensitivity such as rash, fever, lymphadenopathy, facial edema, arthralgias, eosinophilia and/or atypical lymphocytosis.

Latency to Onset. Typically, the time to onset of immunoallergic hepatitis is short, within 1 to 8 weeks of starting the medication and can be as short as 1 to 2 days, particularly with reexposure.

Symptoms. The onset of symptoms of immunoallergic hepatitis is typically abrupt, with appearance of fever and or rash, followed by nonspecific symptoms of liver injury such as fatigue, nausea, right upper quadrant pain and poor appetite, and then by dark urine and jaundice. Pruritus may also arise early. The rash is usually maculopapular, but can be urticarial and in severe cases can evolve into toxic epidermal necrolysis or Stevens Johnson syndrome. Fever can be prominent and persist into the period of jaundice. Other allergic manifestations include arthralgias, facial edema and lymphadenopathy. Early in the course there may be prominent eosinophilia or atypical lymphocytosis. The allergic manifestations typically begin to improve with onset of jaundice.

Serum Enzyme Elevations. The pattern of serum enzyme elevations in immunoallergic hepatitis is typically cholestatic or mixed, with serum aminotransferase levels ranging from 120 to 400 IU/L (3 to 10 times ULN) and alkaline phosphatase >345 IU/L (>3 times ULN). More rarely, there is an acute viral hepatitis-like or acute hepatic necrosis clinical pattern. In either situation, the term "immunoallergic" can be added, such as "cholestatic hepatitis with immunoallergic features."

Drugs. The drugs that typically cause immunoallergic hepatitis include the sulfonamides, macrolide and fluoroquinolone antibiotics, penicillins (all four generations), celecoxib, allopurinol, nevirapine, efavirenz, and the aromatic anticonvulsants (phenytoin, phenobarbital, carbamazepine, and lamotrigine).

Criteria for Definition. Important elements in defining immunoallergic hepatitis include:

1 Time to onset of less than 8 weeks
2 Rash (lasting at least 3 days or observed by medical care providers)
3 Fever (lasting at least 3 days or documented as >38.5 °C)
4 Eosinophilia (>7% or >500 cells/µL) or atypical lymphocytosis (>5% or >500 cells/µL) on blood counts taken within 2 weeks of onset
5 Facial edema (periorbital, perioral, cervical or diffuse) or lymphadenopathy or arthralgias
6 Rapid recurrence of serum enzyme elevations and either fever or rash with rechallenge
7 Exposure to an agent known to cause immunoallergic hepatitis: sulfonamides, penicillins, macrolides, fluoroquinolones, nevirapine, efavirenz, allopurinol or aromatic anticonvulsants.

A subcategory of immunoallergic hepatitis is the DRESS syndrome (drug reaction with eosinophilia and systemic symptoms). The rash accompanying immunoallergic hepatitis can be severe with Stevens Johnson syndrome or toxic epidermal necrolysis. In these situations, the signs of hypersensitivity may overshadow the liver injury, which can be mild. On the other hand, mild symptoms of hypersensitivity (low grade fever, transient erythematous rash, mild eosinophilia) are not uncommon with any form of acute liver injury including viral hepatitis, and the term immunoallergic hepatitis should be reserved for cases in which the symptoms and signs of hypersensitivity are prominent.

Mechanism of Injury. The presence of signs and symptoms of hypersensitivity provide convincing evidence that the liver injury is immunologically mediated. HLA associations have been identified for some forms of immunoallergic hepatitis due to medications, but the basis of the immune reaction has yet to be shown.

Management and Outcome. In cases of severe immunoallergic hepatitis, the symptoms and signs of hypersensitivity often lead to use of corticosteroids. Anecdotal reports suggest that corticosteroids are helpful for the allergic manifestations such as fever, rash and lymphadenopathy, but their role in ameliorating the liver injury is uncertain. Severe forms of cholestatic immunoallergic hepatitis can evolve into vanishing bile duct syndrome and, indeed, pruritus and jaundice may first arise as the hypersensitivity features resolve. In addition, severe immunoallergic hepatitis with a hepatocellular pattern of injury can evolve into acute liver failure and result in death or need for liver transplantation. Again, the role of corticosteroids in ameliorating either of these outcomes of immunoallergic hepatitis is uncertain.

## Representative Cases

### Case 1. Mild immunoallergic hepatitis due to trimethoprim/sulfamethoxazole.

(DILIN Case: 104-0036)

A 33 year old woman was treated with a 21 day course of trimethoprim/sulfamethoxazole (TMP-SMZ) (80 mg/400 mg) for sinusitis. One day after stopping therapy, she developed a macular rash, fever, right upper quadrant abdominal pain and nausea. Three days later she was seen in an emergency room and found to have fever, rash and systemic symptoms, and was hospitalized (Table). She had elevations in ALT and alkaline phosphatase, but serum bilirubin levels remained in the normal range. She had no history of liver disease, high risk behaviors, or exposures to viral hepatitis. She drank little alcohol (1 to 2 drinks per week) and took no other medications except for multivitamins and an occasional ibuprofen. Blood counts were normal except for mild eosinophilia (7%). Tests for hepatitis A, B and C were negative as were autoantibodies. Ultrasound of the liver was normal without gallstones. Her fever and rash resolved and she was discharged with a diagnosis of sulfonamide hypersensitivity reaction. Liver tests fell into the normal range within 4 weeks on onset of symptoms.

#### Key Points

Medication: | Trimethoprim (80 mg)/sulfamethoxazole (400 mg)
Pattern: | Hepatocellular (R=14)
Severity: | 1+ (no jaundice)
Latency: | 3 weeks
Recovery: | 4 weeks
Other medications: | Multivitamins, ibuprofen

#### Laboratory Values

Time After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
25 days | 4 days | 981 | 195 | 0.5 | Hospitalization
26 days | 5 days | 805 | 213 | 0.8 | Normal ultrasound
4 weeks | 6 days | 623 | 316 | 1.1 | Discharged
5 weeks | 2 weeks | 156 | 386 | 0.6 | Asymptomatic
6 weeks | 3 weeks | 49 | 168 | 0.4
8 weeks | 7 weeks | 34 | 77 | 0.4
Normal Values | | <45 | <130 | <1.2

#### Comment

This patient had typical but mild immunoallergic hepatitis with fever, rash, constitutional symptoms, eosinophilia and ALT elevations, appearing within 3 weeks of starting TMP/SMZ and resolving rapidly once it was stopped. Despite the height to the ALT elevations, the liver injury was mild, minimally symptomatic and not associated with jaundice or hepatic synthetic dysfunction. Some degree of ALT or alkaline phosphatase elevations is common in patients who have hypersensitivity reactions to sulfonamides and might be missed if blood testing is not done. The patient should be warned against future exposure to sulfonamides; with second exposures the liver injury can become more acute and more severe.

### Case 2. Immunoallergic hepatitis caused by carbamazepine.

[Modified from: Dertinger S, Dirschmid K, Vogel W, Drexel H. Immunosuppressive therapy for carbamazepine-induced hypersensitivity syndrome and hepatitis. J Hepatol 1998; 28: 356-7. PubMed Citation]

A 50 year old man with epilepsy was switched from valproate to carbamazepine and presented with high fevers and fatigue one month later. He was treated with amoxicillin and developed a diffuse maculopapular rash, adenopathy and jaundice within a few days. Laboratory testing showed eosinophilia (8%) and elevations in serum enzymes with mild jaundice (Table). Tests for viral hepatitis, autoimmune liver disease and liver imaging were negative or nonrevealing. Carbamazepine was continued for another 5 days when a liver biopsy showed evidence of drug induced liver disease. Because of worsening rash and hemorrhagic bullae, a single intravenous injection of prednisolone (250 mg) was given. He improved rapidly and was discharged after 12 days in the hospital, but returned a few days later with relapse in fever, rash and fatigue. Serum enzymes had risen as well. He was started on oral prednisone (~40 mg/day) and improved. The dose of prednisone was gradually decreased and was stopped 12 weeks later. In follow up, he was asymptomatic and had normal liver tests on chronic valproate therapy.

#### Key Points

Medication: | Carbamazepine (600 mg/day)
Pattern: | Mixed (R=4.6)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 weeks
Recovery: | Complete in 6 weeks
Other medications: | Amoxicillin after onset of fever (valproate in the past)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
4 weeks | 0 | 166 | 365 | 3.9 | 8% eosinophils
| 1 day | 334 | 311 | 5.2 | Given iv prednisolone
Discharged after 12 days in hospital and readmitted 4 days later
6 weeks | 12 days | 324 | 452 | 2.2 | Fever, fatigue, and worsening rash
7 weeks | 2 weeks | 221 | 356 | 1.6 | Prednisone 1 mg/kg/day
2 months | 3 weeks | 85 | 240 | 1.3 | Prednisone tapered
3 months | 5 weeks | 15 | 82
4 months | 3 months | 14 | 64 | 0.3 | Prednisone stopped
6 months | 5 months | 15 | 76 | 0.3
Normal Values | | <42 | <115 | <1.2

#### Comment

A typical case of drug related rash with eosinophilia and systemic symptoms (DRESS), also referred to as anticonvulsant hypersensitivity syndrome or immunoallergic hepatitis due to carbamazepine. The presentation and course were typical with onset of fever, rash, lymphadenopathy, eosinophilia and a mixed-hepatocellular-cholestatic form of liver injury within 4 weeks of starting carbamazepine. The course of the liver disease was relatively mild and dominated by the systemic symptoms of fever and rash. While corticosteroids have not been proven to be beneficial in drug induced liver injury, this case demonstrates that they appear to rapidly ameliorate symptoms and signs of hypersensitivity, as evidenced in this patient by the rapid response in rash and fever to a single infusion of prednisone and the relapse in symptoms when corticosteroids were not continued. While corticosteroids may shorten the period of symptoms, they have not been shown to alter the ultimate outcome which is usually complete recovery. For this reason, corticosteroids should be used cautiously, limiting the dose and duration of therapy and, as in this case, documenting sustained recovery after withdrawal.

### Case 3. Severe acute immunoallergic hepatitis due to nevirapine.

[Modified from: Knudtson E, Para M, Boswell H, Fan-Havard P. Drug rash with eosinophilia and systemic symptoms syndrome and renal toxicity with a nevirapine-containing regimen in a pregnant patient with human immunodeficiency virus. Obstet Gynecol 2003; 101(5 Pt 2): 1094-7. PubMed Citation]

A 26 year old pregnant woman with HIV infection developed fever and skin rash 6 weeks after starting triple antiretroviral therapy with nevirapine, lamivudine and zidovudine. Before therapy, her CD4 count was 614 cells/µL, HIV RNA level was 1642 copies/mL, and liver tests were normal. On admission at 32 weeks gestation, she was febrile and jaundiced and had a diffuse urticarial rash. Laboratory tests showed eosinophilia and a cholestatic pattern of serum enzyme elevations (Table). Tests for hepatitis A, B and C and for EBV and CMV infection were negative as were autoantibodies. Ultrasound of the liver showed no evidence of obstruction. Nevirapine was stopped and she was given corticosteroids. Over the next few days she continued to worsen and emergency Caesarian section was done. Thereafter, she began to improve and was discharged 4 days after delivery. In follow up, she was asymptomatic, had normal liver test results and the child was well and without evidence of HIV infection.

#### Key Points

Medication: | Nevirapine (200→400 mg daily)
Pattern: | Cholestatic (R=1.6)
Severity: | 4+ (jaundice, hospitalization and features of hepatic failure)
Latency: | 6 weeks
Recovery: | Complete
Other medications: | Lamivudine, zidovudine, 2 days of acetaminophen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 14 | | 0.4
2 weeks | | 14 | 77 | 0.4
6 weeks | 0 | 235 | 257 | 12.0 | INR 2.4, given betamethasone
| 2 days | 404 | 175 | 15.3 | INR 3.6, fresh frozen plasma
| 4 days | 966 | 201 | 19.4 | Fever, 20% eosinophilia
Emergency Caesarian Section
7 weeks | 6 days | 746 | 239 | 20.2 | Oral prednisone
| 8 days | 696 | 466 | 16.9
8 weeks | 2 weeks | 509 | 500 | 7.0 | Discharged
6 months | 4 months | 18 | 73 | 0.4
Normal Values | | <61 | <106 | <1.2

#### Comment

A very characteristic example of the DRESS syndrome (drug rash with eosinophilia and systemic symptoms) due to nevirapine in a woman with HIV infection and a CD4 count above 250/µL. The associated immunoallergic hepatitis was severe with bilirubin levels reaching 20 mg/dL and prolongation of prothrombin time. While the clinical course was also compatible with pregnancy associated HELPP syndrome, the timing and immunoallergic features suggest that nevirapine was the major cause. Women may be more susceptible to the immunoallergic hepatitis caused by nevirapine, and pregnancy may increase the risk further. Corticosteroids are often used in patients with severe immunoallergic hepatitis and they appear to improve many of the manifestations of hypersensitivity, but their efficacy in altering the ultimate outcome of the liver injury has not been proven.

### Case 4. Fatal immunoallergic hepatitis due to allopurinol.

[Modified from: Raper R, Ibels L, Lauer C, Barnes P, Lunzer M. Fulminant hepatic failure due to allopurinol. Aust NZ J Med 1984; 14: 63-5. PubMed Citation]

A 58 year old woman with diabetes, hypertension, gastric ulcer and gouty arthritis with hyperuricemia and mild renal insufficiency was started on allopurinol (300 mg daily) and developed fever and rash 17 days later. She had undergone resection of a parathyroid adenoma under enflurane anesthesia shortly after starting allopurinol, but she recovered uneventfully and was sent home on doxycycline in addition to her usual medications including glibenclamide, indomethacin and cimetidine. One week later she developed fever, fatigue and rash which became generalized and exfoliative. Allopurinol was stopped and she was admitted for observation. She was markedly febrile (39 oC) and had a generalized erythematous rash. Blood testing showed leukocyotosis and eosinophilia. Liver tests, which were previously normal, were mildly elevated on admission, but over the next few days worsened with onset of jaundice (Table). Tests for hepatitis A and B were negative. She subsequently developed progressive prolongation of the prothrombin time followed by confusion, encephalopathy and ascites. Corticosteroids were started. She developed gram negative sepsis followed by multiorgan failure and died. Postmortem liver biopsy showed marked centrilobular necrosis, cholestasis, inflammation and small islands of regenerating hepatocytes.

#### Key Points

Medication: | Allopurinol (300 mg daily)
Pattern: | Mixed (R=2.2)
Severity: | 5+ (death from hepatic failure)
Latency: | 3 weeks
Recovery: | None
Other medications: | Glibenclamide, indomethacin, and cimetidine chronically; enflurane 2 weeks before onset, doxycycline for the 6 days before onset

#### Laboratory Values

Time After Stopping | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Allopurinol started (300 mg daily) for gout
4 days | | 25 | 100 | 0.5 | Preoperative testing
17 days | 0 | 110 | 120 | 0.5 | Admission: rash and fever
4 weeks | 11 days | 1240 | 1240 | 12.0 | Prothrombin time 9 sec prolonged
6 weeks | 25 days | 65 | 390 | 30.0 | Ascites, coma and sepsis
Normal Values | | <40 | <195 | <1.2

#### Comment

This patient developed a severe allopurinol hypersensitivity syndrome 3 weeks after starting therapy. Hepatotoxicity due to allopurinol has a high fatality rate (~10%). Risk factors for allopurinol hepatotoxicity include renal insufficiency and African or African-American race. This patient developed jaundice several days after being admitted for rash and fever and subsequently worsened with development of hepatic failure. This syndrome is also referred to as DRESS (drug rash with eosinophilia and systemic symptoms) and is usually rapidly reversible with stopping the medication. However, the hypersensitivity reaction can be severe and result in death from acute liver failure or from complications of generalized skin rash (toxic epidermal necrolysis, Stevens Johnson syndrome) or renal disease. Corticosteroid therapy is often given and usually results in rapid disappearance of fever and improvement in rash, but relapse with stopping corticosteroids is common and this therapy is of unproven benefit for the hepatic injury and can complicate management of acute liver failure.

## Selected References

Young JL, Boswell RB, Nies AS. (1974). Severe allopurinol hypersensitivity. Association with thiazides and prior renal compromise. Arch Intern Med. (40 year old man and 67 year old woman developed fever, rash and eosinophilia 4 weeks after starting allopurinol [bilirubin 2.0 and 1.8 mg/dL, AST 1550 and 210 U/L], one patient dying of liver [bilirubin rising to 15.0 mg/dL] and renal failure, and the other surviving; preexisting renal insufficiency, thiazide use and African-American race were thought to be risk factors).
Lang PG. (1979). Severe hypersensitivity reactions to allopurinol. South Med J. (Retrospective analysis of 20 cases of allopurinol hypersensitivity seen at 3 Atlanta hospitals 1973-78; 13 blacks, mean age 59 years, 11 with preexisting renal disease, 5 on thiazides; onset after 1-6 weeks often with rash, which was macropapular [9], exfoliative [6] or toxic epidermal necrolysis [5]; 6 had liver involvement [bilirubin 1.4-13.8 mg/dL, AST 56-4000 U/L and Alk P 117-450 U/L], 9 had renal involvement, 4 died of complications of skin involvement and sepsis).
Raper R, Ibels L, Lauer C, Barnes P, Lunzer M. (1984). Fulminant hepatic failure due to allopurinol. Aust NZ J Med. (58 year old Chinese woman developed fever and exfoliative rash 3 weeks after starting allopurinol with eosinophilia, jaundice and fulminant course [bilirubin 12 rising to 30 mg/dL, ALT 1240 U/L, Alk P 1240 U/L]: Case 4).
Dertinger S, Dirschmid K, Vogel W, Drexel H. (1998). Immunosuppressive therapy for carbamazepine-induced hypersensitivity syndrome and hepatitis. J Hepatol. (50 year old man developed fever, headaches, rash, and lymphadenopathy followed by jaundice 1 month after starting carbamazepine [bilirubin 3.9 mg/dL, ALT 166, Alk P 365 U/L], responding to single dose of prednisone and then transiently relapsing: Case 2).
Knowles SR, Shapiro LE, Shear NH. (1999). Anticonvulsant hypersensitivity syndrome: incidence, prevention and management. Drug Saf. (Review of anticonvulsant hypersensitivity syndrome: triad of fever, rash and internal organ injury occurring 1-8 weeks after exposure to anticonvulsant; liver being most common internal organ involved. Occurs in 1:1000-1:10,000 initial exposures to phenytoin, carbamazepine, phenobarbital or lamotrigine, unrelated to dose, perhaps predisposed by valproate; liver injury arises 1-4 weeks after onset of rash and ranges in severity from asymptomatic ALT elevations to icteric hepatitis to ALF. High mortality rate with jaundice; other organs include muscle, kidney, brain, heart and lung. Role of corticosteroids uncertain; cross reactivity among the agents should be assumed).
Descamps V, Valance A, Edlinger C, Fillet AM, Grossin M, Lebrun Vignes B, Belatch S, et al. (2001). Association of human herpes virus 6 infection with drug reaction with eosinophilia and systemic symptoms. Arch Dermatol. (Among 7 patients with drug rash with eosinophilia and systemic symptoms [DRESS] syndrome, all had anti-HHV-6, 2 in rising titers, 4 with IgM, none had HHV-6 DNA: 5 cases from carbamazepine, 1 sulfasalazine and 1 ibuprofen).
Knudtson E, Para M, Boswell H, Fan-Havard P. (2003). Drug rash with eosinophilia and systemic symptoms syndrome and renal toxicity with a nevirapine-containing regimen in a pregnant patient with human immunodeficiency virus. Obstet Gynecol. (26 year old pregnant woman with CD4 count of 614 developed rash and fever 6 weeks after starting lamivudine, zidovudine and nevirapine [9.6% eosinophilia, bilirubin 12 mg/dL, ALT 235 U/L, Alk P 257 U/L, INR 2.4], who worsened despite stopping nevirapine and receiving corticosteroids; had emergency Caesarian with subsequent recovery: Case 3).
Tohyama M, Hashimoto K, Yasukawa M, Kimura H, Horikawa T, Nakajima K, Urano Y, et al. (2007). Association of human herpes virus 6 reactivation with the flaring and severity of drug-induced hypersensitivity syndrome. Br J Dermatol. (Anti-HHV-6 testing of 100 patients with drug induced hypersensitivity syndrome [34% with hepatitis] found rise in IgG levels in 62 patients, largely in more severe cases; HHV-6 DNA detected in 18; drugs included carbamazepine, phenobarbital, phenytoin, allopurinol, sulfasalazine and mexiletine).
Bjöson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Ata Neurol Scan. (Review of all anticonvulsants; phenytoin usually causes liver injury as a part of the hypersensitivity syndrome, in 1:10,000 to 1:50,000 persons, 100 published cases, mean onset at 4 weeks, 13% mortality).
Franciotta D, Kwan P, Perucca E. (2009). Genetic basis for idiosyncratic reactions to antiepileptic drugs. Curr Opin Neurol. (Review of the genetic associations with hypersensitivity reactions to anticonvulsant medications; closest association has been with HLA-B*1502 and Stevens Johnson syndrome after aromatic anticonvulsants).
Eshki M, Allanore L, Musette P, Milpied B, Grange A, Guillaume JC, Chosidow O, et al. (2009). Twelve-year analysis of severe cases of drug reaction with eosinophilia and systemic symptoms: a cause of unpredictable multiorgan failure. Arch Dermatol. (Retrospective analysis of 15 patients with severe drug rash with eosinophilia and systemic symptoms [DRESS] syndrome from France; 2/3rds were women, ages 15-71, mean onset 18 days; 4 due to allopurinol, 3 minocycline, 3 anticonvulsants and 3 sulfonamides; severe manifestations including hepatitis [n=7], pneumonitis [10], renal failure [5], encephalitis [2], pancytopenia [2], heart failure [1]).

## Hepatic Histology in Immunoallergic Hepatitis

[Under Construction]